# Desirudin

## OVERVIEW

### Introduction

Desirudin is a parenterally administered, selective thrombin inhibitor that is used to decrease the risk of deep vein thrombosis and pulmonary embolus in patients undergoing hip replacement surgery. Desirudin has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury with jaundice.

### Background

Desirudin (des" i roo' din) is a recombinant 65 amino acid peptide analogue of hirudin, the naturally occurring anticoagulant found in the salivary glands of leeches (Hirudo medicinalis). Hirudin is a mixture of similar peptides that actively bind to and inactivate thrombin. Like human antithrombin, hirudin binds to both circulating and fibrinogen bound thrombin and thus both prevents and dissolves clots and thrombi. In clinical trials, desirudin given during and after hip replacement surgery was equivalent or slightly better than heparin in decreasing the frequency of deep vein thrombosis and pulmonary emboli during the perioperative period. Desirudin was approved for use in the United States in 2003 and has been used in limited numbers of patients. Current indications are limited to reduction of the risk of deep vein thrombosis and pulmonary embolization after elective hip replacement surgery. Desirudin is available in single use vials of 15.75 mg under the commercial name Iprivask. The usual dose is an injection of 15 mg subcutaneously immediately before surgery and twice daily for 8 to 12 days. The most common side effect is bleeding; other side effects are not common, but can include hypersensitivity reactions, including anaphylaxis. Hypersensitivity reactions are particularly common and more likely to be severe in persons who have been previously treated with desirudin or other hirudin analogues such as bivalirudin.

### Hepatotoxicity

In the large prelicensure clinical trials of desirudin, serum aminotransferase and alkaline phosphatase elevations were not reported. Furthermore, there have been no case reports of clinically apparent liver injury attributable to desirudin therapy. There have been reports of hypersensitivity reactions to desirudin therapy and hepatic involvement often occurs during severe drug induced hypersensitivity reactions.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Desirudin is a recombinant protein and is unlikely to have intrinsic hepatotoxicity. Liver injury during desirudin therapy is clearly rare, if it occurs at all, and would most likely be part of an immunologic reaction to the foreign protein.

### Outcome and Management

There appears to be cross sensitivity to allergic reactions to various preparations of recombinant hirudins and retreatment with desirudin should be avoided.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants, Thrombin Inhibitors: Dabigatran

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Desirudin – Iprivask®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Desirudin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Desirudin | 120993-53-5 | Protein | Complex Polypeptide

## ANNOTATED BIBLIOGRAPHY

References updated: 03 January 2018

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-412. (Textbook of hepatotoxicity published in 1999; heparin, low molecular weight heparins and ticlopidine are discussed, but not desirudin).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 528. (Review of hepatotoxicity of cardiovascular drugs does not discuss anticoagulants or desirudin).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Eriksson BI, Ekman S, Kälebo P, Zachrisson B, Bach D, Close P. Prevention of deep-vein thrombosis after total hip replacement: direct thrombin inhibition with recombinant hirudin, CGP 39393. Lancet 1996; 347 (9002): 635-9. (Among 1119 patients undergoing hip replacement surgery who were treated with one of 3 doses of desirudin or heparin for 8-11 days, thromboembolism was less frequent in desirudin treated subjects [18%-24% vs 34%], with no difference in rate of bleeding; no mention of hepatotoxicity or ALT elevations). 8596376
Eriksson BI, Ekman S, Lindbratt S, Baur M, Bach D, Torholm C, Kälebo P, Close P. Prevention of thromboembolism with use of recombinant hirudin. Results of a double-blind, multicenter trial comparing the efficacy of desirudin (Revasc) with that of unfractionated heparin in patients having a total hip replacement. J Bone Joint Surg Am 1997; 79: 326-33. (Among 445 patients undergoing hip replacement surgery, deep vein thrombosis occurred in 7% of those treated with desirudin for 8-11 days vs 23% given heparin, with no difference in rates of bleeding; no mention of ALT elevations or hepatotoxicity). 9070519
Eriksson BI, Wille-Jørgensen P, Kälebo P, Mouret P, Rosencher N, Bösch P, Baur M, et al. A comparison of recombinant hirudin with a low-molecular-weight heparin to prevent thromboembolic complications after total hip replacement. N Engl J Med 1997; 337: 1329-35. (Among 1587 patients undergoing hip replacement surgery, deep vein thrombosis occurred in 18% of those treated with desirudin for 8-12 days vs 25.5% given enoxaparin, with no differences in rates of bleeding; other side effects including ALT elevations were not mentioned). 9358126
Ewenstein BM. Antithrombotic agents and thromboembolic disease. N Engl J Med 1997; 337: 1383-4. (Editorial in response to Eriksson [N Engl J Med 1997]). 9358134
Roe MT, Granger CB, Puma JA, Hellkamp AS, Hochman JS, Ohman EM, White HD, et al. Comparison of benefits and complications of hirudin versus heparin for patients with acute coronary syndromes undergoing early percutaneous coronary intervention. Am J Cardiol 2001; 88: 1403-6, A6. (Among 1410 patients with acute coronary syndromes undergoing percutaneous interventions who were treated with either hirudin or heparin, myocardial infarction was less frequent with hirudin treatment, but overall survival rates were the same; no discussion of rates of ALT elevations or hepatotoxicity or other nonbleeding side effects). 11741559
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to anticoagulants). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to anticoagulants). 20949552
Desirudin (Iprivask) for DVT prevention. Med Lett Drugs Ther 2010; 52 (1350): 85-6. (Concise review of the mechanism of action, efficacy and safety of desirudin, a recombinant analog of hirudin which is used to prevent deep vein thrombosis and pulmonary embolization after hip replacement surgery; no mention of hepatotoxicity or ALT elevations). 21045759
Antithrombotic drugs. Treat Guidel Med Lett 2011; 9 (110): 61-6. (Guidelines on the use of antiplatelet drugs including aspirin, clopidogrel, prasugrel, ticagrelor and ticlopidine mentions that prasugrel appears to be more effective than clopidogrel, but has a greater risk of bleeding; no mention of hepatotoxicity or ALT elevations). 21941228
Bergese SD, Minkowitz HS, Arpino PA, Sane DC, Levy JH. Multicenter trial of desirudin for the prophylaxis of thrombosis: an alternative to heparin-based anticoagulation (DESIR-ABLE). Clin Appl Thromb Hemost 2013; 19: 418-23. (Among 516 patients with risk factors for deep vein thrombosis [surgical or medical] treated with desirudin for 1-24 days, thromboembolism events occured in 1.6% of patients and none had major bleeding episodes; no mention of ALT elevations or hepatotoxicity and desirudin is not discussed). 22802554
Jove M, Maslanka M, Minkowitz HS, Jaffer AK; DESIR-ABLE Investigators. Safety of desirudin in thrombosis prevention after total knee arthroplasty: the DESIR-ABLE study. Am J Ther 2014; 21: 496-9. (Analysis of 65 patients treated prophylactically with desirudin from the DESIR-ABLE trial [Bergese] whose surgery was for total hip replacement, showing that none had a major bleeding episode, although 2 had minor episodes and none died or had symptomatic deep venous thromboses; two had asymptomatic thromboses and a nonfatal pulmonary embolus; no mention of ALT elevations or hepatotoxicity). 23344102
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two cases were attributed to anticoagulants (prasugrel and dalteparin), but none to desirudin or the direct thrombin inhibitors or factor Xa antagonists). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Desirudin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Desirudin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Desirudin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Desirudin)